# Ritonavir

## OVERVIEW

### Introduction

Ritonavir is an antiretroviral protease inhibitor that is widely used in combination with other protease inhibitors in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Ritonavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and, rarely, can lead to clinically apparent acute liver injury. In HBV or HCV coinfected patients, highly active antiretroviral therapy with ritonavir may result of an exacerbation of the underlying chronic hepatitis B or C.

### Background

Ritonavir (ri toe' na vir) is peptidomimetic HIV protease inhibitor that acts by binding to the catalytic site of the viral protease, thereby preventing the cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Ritonavir was approved for use in the United States in 1996 and is still widely used in combination with other antiretroviral agents for the prevention and treatment of HIV infection. Ritonavir is available under the brand name Norvir in capsules of 100 mg and as an oral solution (for pediatric use). Ritonavir (50 mg) is also available in a fixed combination with lopinavir (200 mg) under the brand name Kaletra. While originally evaluated and approved to be used in full doses (600 mg twice daily) in combination with nucleoside or nonnucleoside reverse transcriptase inhibitors, ritonavir is now used mostly in a low or “booster” dose (50 to 100 mg twice daily) in combination with other protease inhibitors such as atazanavir, fosamprenavir, indinavir, lopinavir, nelfinavir, and saquinavir. Ritonavir is a potent inhibitor of CYP 3A4 activity in the liver, and in low doses causes a prolongation of the half-life of other protease inhibitors that are metabolized by this pathway. The most common side effects of ritonavir are nausea, diarrhea, gastrointestinal upset, change in taste, fatigue, rash and, with long term use, hyperlipidemia and lipodystrophy.

### Hepatotoxicity

Some degree of serum aminotransferase elevations occurs in a high proportion of patients taking ritonavir containing antiretroviral regimens. Moderate-to severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) are found in up to 15% of patients treated with full doses of ritonavir and are more common in patients with HIV-HCV coinfection. With low “booster” doses, ritonavir does not appear to increase the frequency or severity of serum enzyme elevations, and those that occur are usually asymptomatic and self-limited, resolving even with continuation of ritonavir. Clinically apparent liver injury from full doses of ritonavir has been reported, but hepatotoxicity from low dose ritonavir has not been clearly linked to acute liver injury. In many situations, the liver injury is difficult to attribute to ritonavir because it is used in combination with higher doses of other protease inhibitors. HIV protease inhibitors have been associated with acute liver injury arising 1 to 8 weeks after onset, with variable patterns of liver enzyme elevation, from hepatocellular to cholestatic. Immunoallergic features (rash, fever, eosinophilia) are uncommon as is autoantibody formation. Ritonavir in combination with saquinavir has also been associated with a rapid onset (1 to 4 days) acute hepatic injury in patients who are taking rifampin and perhaps other agents that affect CYP 450 activity, such as phenobarbital. Finally, initiation of ritonavir based highly active antiretroviral therapy can lead to exacerbation of an underlying chronic hepatitis B or C in coinfected individuals, typically arising 2 to 12 months after starting therapy and associated with a hepatocellular pattern of serum enzyme elevations and increases followed by falls in serum levels of hepatitis B virus (HBV) DNA or hepatitis C virus (HCV) RNA. Ritonavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver enzyme elevations during ritonavir therapy is not entirely known. Ritonavir is extensively metabolized by the liver via the cytochrome P450 system (CYP 3A4), which it also inhibits. Thus, production of a toxic intermediate of ritonavir or other agents that are metabolized by CPY 3A4 may underlie liver injury. In patients with HIV and HCV or HBV coinfection, initiation of highly active antiretroviral therapy may be associated with flares of the underlying chronic hepatitis, which may be the result of reconstitution of the immune system, viral interactions or direct effects of the agents on the hepatitis virus.

### Outcome and Management

The rare cases of clinically apparent liver injury attributed to ritonavir have been self-limited, and chronic hepatitis and vanishing bile duct syndrome have yet to be linked to its use. Rechallenge leads to recurrence of liver injury and should be avoided. There is little evidence of cross reactivity among the various protease inhibitors and other agents can usually be safely substituted. The exacerbation of hepatitis B or C that can occur with ritonavir based antiretroviral therapies can be severe and lead to acute liver failure or progressive, end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy instituted if possible.

References to ritonavir are included with references to all the HIV protease inhibitors in the overview section of Protease Inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Indinavir, Lopinavir, Nelfinavir, Saquinavir, Tipranavir

## CASE REPORTS

### Case 1. Precipitation of hepatic steatosis and lactic acidosis by addition of ritonavir to long-term stavudine therapy.

[Modified from: Picard O, Rosmorduc O, Cabane J. Hepatotoxicity associated with ritonavir (letter). Ann Intern Med 1998; 129: 670-1. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9786823)]

A 28 year old woman with HIV infection and AIDS developed serum aminotransferase elevations (133 U/L) five weeks after starting an antiretroviral regimen of ritonavir (1200 mg/day), stavudine and lamivudine. She had been on multiple nucleoside reverse transcriptase inhibitors in the past, including zidovudine, didanosine, zalcitabine and lamivudine and had normal serum aminotransferase levels on several occasions. She did not drink alcohol and tests for hepatitis A, B and C were negative. Despite the ALT elevations, she was asymptomatic and the abnormalities rapidly resolved with stopping antiretroviral therapy. Five weeks after restarting this regimen, however, she developed abdominal pain, nausea and jaundice. She was found to have weight loss, an enlarged and tender liver, and ascites. Serum ALT was 327 U/L, bilirubin 18.0 mg/dL and prothrombin index was 22%. Tests for viral hepatitis were negative. She developed lactic acidosis and encephalopathy. A liver biopsy showed microvesicular steatosis, cholestasis and fibrosis with minimal inflammation. The antiretroviral agents were stopped, and she improved slowly, liver tests being normal 8 weeks later. Lamivudine and stavudine without ritonavir were reintroduced and she remained without evidence of recurrence of liver injury over the next 9 months.

#### Key Points

Medication: | Ritonavir and stavudine
Pattern: | Unclear (no alkaline phosphatase levels)
Severity: | 4+ (encephalopathy and ascites)
Latency: | 5 weeks on initial and re-exposure
Recovery: | Yes
Other medications: | Lamivudine

#### Comment

The clinical course and presentation with hepatic failure, lactic acidosis and hepatic microvesicular steatosis are typical of the mitochondrial liver injury that occurs with the stavudine therapy, and more rarely with didanosine and zidovudine. In this case, the therapy with ritonavir appeared to trigger or aggravate the injury that is usually attributed to stavudine. As in many instances of hepatotoxicity occurring during antiretroviral therapy, it was difficult to attribute the injury to a specific agent and, in this case, the ritonavir appeared to increase the risk of the stavudine related injury, such that without it (on rechallenge), lactic acidosis did not recur. Similar instances of microvesicular fatty liver and lactic acidosis have occurred in patients who have had tenofovir or ribavirin added to long term stavudine therapy. Improvement can occur with stopping either the mitochondrial toxin (stavudine, didanosine, zidovudine) or the ancillary agent (ritonavir, tenofovir, ribavirin). The pathogenesis may relate to drug-drug interactions among the antiretroviral agents.

### Case 2. Exacerbation of chronic hepatitis C during antiretroviral therapy in a patient with HIV-HCV coinfection.

[Modified from: John M, Flexman J, French MA. Hepatitis C virus-associated hepatitis following treatment of HIV-infected patients with HIV protease inhibitors: an immune restoration disease? AIDS 1998; 12: 2289-93. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9863871)]

A 36 year old man with HIV infection developed rise in ALT levels followed by symptoms and jaundice 8 weeks after starting antiretroviral therapy with lamivudine (300 mg/day), stavudine (80 mg/day) and ritonavir (1200 mg/day) (Table). His levels of HIV RNA had fallen (5.5 to <2.6 log10 copies/mL) and CD4 counts had risen (32 to 138 per μL) on antiretroviral therapy. He had no recent risk factors for viral hepatitis and ultrasound showed no evidence of biliary obstruction. A liver biopsy showed chronic hepatitis. He tested negative for hepatitis A and B, but for the first time, was reactive for anti-HCV. Testing of stored serum specimens demonstrated that HCV RNA was present at moderately high levels (5.8 log10 copies/mL) for at least two years before initiation of antiretroviral therapy. Treatment was stopped and serum aminotransferase levels improved slowly and incompletely. Restarting therapy using stavudine, didanosine and indinavir was followed by a further worsening of serum aminotransferase levels, which also did not improve with alpha interferon or with prednisolone therapy, but which eventually fell to baseline after stopping HIV therapy whereupon HIV RNA levels rose to baseline.

#### Key Points

Medication: | Ritonavir, lamivudine, stavudine
Pattern: | Probably hepatocellular (alkaline phosphatase levels not provided)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 8 weeks
Recovery: | Incomplete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | HCV RNA (log10 copies/mL) | HIV RNA (log10 copies/mL) | Other
Pre | | 52 | 5.8 | 5.5 | CD4=32/μL
Antiretroviral therapy started (stavudine, lamivudine and ritonavir)
2 months | | 105 | | <2.6
6 months | 0 | 310 | 6.0 | <2.6 | CD4=138/μL
Antiretroviral therapy stopped
7 months | 4 weeks | 260 | | | Anti-HCV +
8 months | 8 weeks | 270 | | 5.6
Antiretroviral therapy restarted (stavudine, didanosine and indinavir)
3 weeks | | 530 | 6.2 | 3.5
7 weeks | | 560 | 6.3 | <2.6
11 weeks | | 270 | 6.4 | | Interferon
15 weeks | | 405 | 6.0 | <2.6 | Interferon
19 weeks | | 510 | | <2.6 | Prednisolone
Antiretroviral, interferon and corticosteroid therapy stopped
6 months | 4 weeks | 245 | 5.8 | 5.5
7 months | 8 weeks | 170 | 5.8
Normal Values | | <40

* All values estimated from Figure 1.

#### Comment

The clinical course suggested that the liver injury represented a worsening of chronic hepatitis C during highly active antiretroviral therapy (two nucleoside analogues and one protease inhibitor) caused by immune reconstitution. Supportive of this hypothesis was the correlation between increases in ALT levels and the rises in CD4 counts (and falls in HIV viral levels). Most convincing was the appearance of anti-HCV at the time of the exacerbation of hepatitis C and worsening with rechallenge using another antiretroviral regimen. These findings suggest that some of the hepatotoxicity of highly active antiretroviral therapy in HIV-HCV coinfected individuals may not be the direct effect of the antiretroviral agents on the liver, but rather their indirect effect in improving immune reactivity. Without more reliable serological or virological markers for disease severity in hepatitis C, it is difficult to attribute the worsening to hepatitis C alone. Thus, levels of HCV RNA did not correlate consistently with fluctuations in serum ALT and IgM anti-HCV levels have not been found to correlate with disease severity in hepatitis C (in contrast to IgM anti-HBc levels in hepatitis B). Furthermore, in larger prospective studies of HIV-HCV infected patients, little correlation has been found between changes in HIV RNA levels or CD4 counts and ALT elevations. While HIV-HCV coinfected patients are more likely than HIV monoinfected patients to develope ALT elevations on antiretroviral therapy, the role of immune reconstitution in these elevations has yet to be defined. These problems point to the need for better therapies of hepatitis C for HIV infected patients.

### Case 3. Exacerbation of chronic hepatitis B during antiretroviral therapy in a patient with HIV-HBV coinfection.

[Modified from: Carr A, Cooper DA. Restoration of immunity to chronic hepatitis B infection in HIV-infected patient on protease inhibitor. Lancet 1997; 349: 995-6. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9100629)]

A 34 year old man with HIV-HBV coinfection developed an abrupt rise in ALT levels (Table) 5 weeks after initiation of antiretroviral therapy with ritonavir (500 mg twice daily). Ritonavir was stopped, but ALT levels remained high. He was known to have serum HBsAg and HBeAg for several years, but serum aminotransferases had always been normal or “near normal.” Serological tests for hepatitis A, C and D (delta) were negative and ultrasound of the abdomen showed no evidence of biliary obstruction. A liver biopsy showed chronic hepatitis with an acute lobular component. He slowly improved and 6 months later was found to have become HBeAg-negative and anti-HBe-positive, with a marked decrease in HBV DNA levels and fall of ALT to near normal levels.

#### Key Points

Medication: | Ritonavir (500 mg twice daily)
Pattern: | Hepatocellular (alkaline phosphatase not given)
Severity: | 1+ and symptomatic (bilirubin levels not given)
Latency: | 5 weeks
Recovery: | 24 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | HBV RNA (log10 copies/mL) | CD4 Count (cells/microL) | Other
Pre | | 80 | 8.8 | 138
1 week | | 75 | 9.1
2 weeks | | 65 | 9.1 | 300
3 weeks | | 70 | 9.2 | 250
4 weeks | | 120 | 9.2 | 250
5 weeks | 0 | 305 | | 270
Ritonavir stopped at week 5
6 weeks | 1 week | 580 | 8.9 | 100 | Symptoms
8 weeks | 3 weeks | 475 | 8.8 | 160
10 weeks | 5 weeks | 640 | 8.1 | 140
12 weeks | 7 weeks | 400 | 6.5
6 months | 5 months | 65 | 5.0 | 70 | HBeAg neg
Normal Values | | <40

* All values estimated from Figure 1.

#### Comment

The clinical course was typical of HBeAg seroconversion, with a flare of hepatitis B preceding marked fall in HBV DNA levels and loss of HBeAg and development of anti-HBe. Typically, serum aminotransferase levels improve with the loss of HBeAg. The relationship of this sudden change in chronic hepatitis B to the initiation of therapy with ritonavir suggests that the improvement in immune reactivity caused the clearance of HBeAg. Spontaneous loss of HBeAg is uncommon in immunosuppressed patients and sudden restoration of immune responses may well trigger this serologic event. In recent years, this phenomenon may be more common with use of antivirals that are active against HBV as well as HIV (such as lamivudine, tenofovir and emtricitabine). Initiation of therapy with these agents can also trigger a flare in hepatitis B that often precedes loss of HBeAg or improvement in serum ALT and HBV DNA levels. Patients with HIV-HBV coinfection should be treated for both viral infections concurrently.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ritonavir – Norvir®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ritonavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ritonavir | 155213-67-5 | C37-H48-N6-O5-S2 | Ritonavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Ritonavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ritonavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ritonavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ritonavir)